# Acute Liver Failure

Description. Drug induced acute liver failure is defined by the appearance of signs or symptoms of hepatic failure and encephalopathy during the course of acute drug induced liver injury in a patient without previous or underlying chronic liver disease.

Latency to Onset. The time to onset of acute liver failure after starting a medication ranges from a few days to many months, but it is rarely greater than 6 months.

Symptoms. Symptoms are those of severe acute liver injury, usually with a prodromal period of fatigue, nausea, poor appetite and right upper quadrant discomfort followed by dark urine and jaundice followed by signs or symptoms of hepatic failure. The diagnosis of acute liver failure is actually based upon the appearance of clinical symptoms of hepatic encephalopathy, such as mental clouding, confusion, asterixis, somnolence, stupor and coma. Other features of liver failure include abdominal swelling due to ascites, peripheral edema and coagulopathy. The rapidity of onset of the symptoms of hepatic encephalopathy varies greatly. Cases in which symptoms of encephalopathy arise within days of onset of hepatitis are usually referred to as "hyperacute", within 5 days to 8 weeks of onset as "acute", and after 8 weeks of onset as "subacute". Initial symptoms of hepatic encephalopathy may be subtle and include a change in personality, forgetfulness, reversal of day-night pattern of wakefulness, and irrational or violent behavior.

Serum Enzyme Elevations. At the time of onset, serum enzymes are usually markedly elevated with serum alanine and aspirate aminotransferase levels 10 to 100 times the upper limit of the normal range, accompanied by mild or at most moderate elevations in alkaline phosphatase levels. As the hepatic failure progresses, hepatocellular pattern may become mixed or actually cholestatic as the aminotransferase levels typically fall, even as laboratory evidence of hepatic failure worsens (progressive rise in serum bilirubin, fall in albumin and rise in prothrombin time or INR). At this same time, alkaline phosphatase levels may rise yielding a more cholestatic pattern.

Drugs. Acetaminophen overdose (either intentional or unintentional) is the most common cause of acute liver failure in the United States and much of the developed world. Other agents that have been implicated in causing acute liver failure include isoniazid, pyrazinamide, nitrofurantoin, phenytoin, carbamazepine, valproate, disulfiram, propylthiouracil, diclofenac, terbinafine, ketoconazole, flutamide, the sulfonamides, fluoroquinolone antibiotics, macrolide antibiotics, and miscellaneous herbal agents. Acute liver failure is a frequent reason for withdrawal or restriction of availability of a medication (troglitazone, bromfenac, nefazodone, halothane, telithromycin).

Differential Diagnosis. Acute liver failure is a distinctive syndrome that is not confused with other conditions. The major differential diagnosis is in the cause of the acute liver failure, whether viral (hepatitis A, B, C, D or E), autoimmune, metabolic (Wilson disease), drug induced or idiopathic.

Definition. The diagnosis of acute liver failure requires the finding of liver test abnormalities indicative of acute liver injury, accompanied by signs or symptoms of hepatic encephalopathy in a patient with no known previous liver injury. Similar acute liver injury accompanied by signs of hepatic failure in a patient with previous, underlying liver disease is more properly called "acute-on-chronic" liver failure. Typical features of acute liver failure include:

1 Acute elevations in serum enzyme elevations with serum aminotransferase levels greater than 10 times the upper limit of the normal range, early in the course of illness
2 Mild to moderate elevations in serum alkaline phosphatase levels (early in the injury)
3 Latency of a few days to 6 months after starting the medication
4 Increased prothrombin time (>3 seconds prolonged) or international normalized ratio (INR >1.5)
5 Symptoms or signs of hepatic encephalopathy.

Other causes of acute liver failure that need to be excluded include acute hepatitis A, B, C, D and E, reactivation of hepatitis B, Wilson's disease, ischemic hepatitis and tumor replacement of the liver. Importantly, a proportion of cases of acute liver failure are "indeterminate" and the etiology is unclear despite careful medical history and extensive laboratory testing and imaging of the liver. Indeterminate acute liver failure accounts for up almost half of cases of acute liver failure in children and approximately 15% in adults. Some of these cases may be due to autoimmune hepatitis. Others are probably due to unacknowledged use of acetaminophen and a medication that was not remembered or was concealed. However, because drug induced liver injury is largely a diagnosis of exclusion and because idiopathic acute liver failure can never be completely excluded, the attribution of acute liver failure to a medication should be done cautiously. The most convincing evidence in favor of a medication is the time of onset of injury (if within 5 to 90 days of starting the medication) and whether the medication has been previously linked to cases of acute liver failure.

Acute liver failure arises typically in patients with acute hepatocellular injury with an acute viral hepatitis like phenotype. Acute hepatic necrosis can also lead to acute liver failure, generally with a hyperacute presentation. Finally, sinusoidal obstruction syndrome and acute fatty liver with lactic acidosis may cause acute liver failure, but clinical features are usually quite different and different medications are typically implicated.

Management and Outcome. Management of acute liver failure due to a medication requires careful attention to all details of medical management and is best done at a medical center at which liver transplantation is available. The first priority is to stop the implicated medication, but also to minimize any further liver damage. For this reason, it is often best to stop all medications and herbals, except those that are life sustaining. There are no specific antidotes for most causes of acute liver failure except of N-acetylcysteine (NAC), which has been shown to decrease hepatic injury due to acetaminophen overdose. Furthermore, a multicenter controlled trial of NAC in patients with acute liver failure not due to acetaminophen indicated that a 3 day course of intravenous NAC was associated with an improvement in spontaneous (transplant-free) survival in patients with drug induced liver injury. Thus, it is reasonable to administer NAC to all patients with severe drug induced acute liver injury suggestive of hepatic failure. Details on the management of acute liver failure with regular updates (position paper and management guidelines) are available at the website of the American Association for the Study of Liver Diseases: https://www.aasld.org/practice-guidelines/management-acute-liver-failure

## CASE REPORTS

### Case 1. Acute liver failure due to combination antituberculosis therapy.(1)

A 60 year old woman with pulmonary tuberculosis was treated with isoniazid (300 mg daily), rifampin (600 mg daily) and pyrazinamide (1.5 grams daily) and improved rapidly but was found to have jaundice with bilirubin 3.5 mg/dL, AST 538 U/L and alkaline phosphatase of 148 U/L six weeks after starting therapy (Table). Her liver tests were reported to be normal before treatment. She had no history of liver disease, alcohol abuse, or risk factors for viral hepatitis. Isoniazid and rifampin were stopped but pyrazinamide continued. One week later she was admitted to a local hospital for worsening hepatic function. She was mildly encephalopathic and the prothrombin time was prolonged. She was transferred to a liver transplant center. She was in stage 3 hepatic coma and required artificial ventilation. Pyrazinamide was stopped and ofloxacin, ethambutol and streptomycin started. Blood tests for hepatitis A, B and C were negative. She underwent successful liver transplantation 5 days after transfer and 3 weeks after onset of symptoms. She recovered uneventfully and was discharged 16 days after transplant on cyclosporine and prednisone. She was maintained on ethambutol, streptomycin and ofloxacin for tuberculosis, and sputum cultures remained negative.

#### Key Points

Medication: | Isoniazid, rifampin, pyrazinamide
Pattern: | Hepatocellular (R=10.1)
Severity: | 5+ (acute liver failure requiring liver transplantation)
Latency: | 6 weeks
Recovery: | No
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Protime (seconds) | Bilirubin (mg/dL) | Other
Pre | | Normal | Normal | Normal
Isoniazid, rifampin and pyrazinamide started for active tuberculosis
6 weeks | 0 | 548 | | 3.5
7 weeks | 7 days | 1640 | 22.4 | 22.4 | Admission
| 20 days | 1100* | 34* | 32.0* | Transfer
8 weeks | 2 weeks | 350* | 41* | 21.0*
| Liver transplantation
3 months | 5 weeks | 30* | 11 | 5.0* | Discharge
Normal Values | | <40 | <14 | <1.2

* Estimated from Figure 2.

#### Comment

This patient developed symptoms of hepatic encephalopathy a week after clinical presentation with an acute hepatitis like syndrome. Antituberculosis medications are perhaps the most common cause of idiosyncratic drug induced acute liver failure, both in the developed and the developing world. This case demonstrates that it is often unclear which of the antituberculosis medications is responsible, and whether the combination of agents is more likely to lead to severe liver injury than the individual agents alone. In this situation, it is best to stop all agents as all three, but particularly isoniazid and pyrazinamide, have been reported to cause acute liver failure. Despite stopping isoniazid therapy promptly, this patient progressed to hepatic failure and required liver transplantation within 3 weeks of initial presentation. Risk factors for isoniazid hepatitis included age and combination therapy. Risk factors for severe outcome were age and sex. After transplantation, the patient tolerated therapy with second-line antituberculosis medications: ethambutol, streptomycin, and ofloxacin.

### Case 2. Acute liver failure due to propylthiouracil.(2)

A 14 year old girl with Graves disease, exophthalmos and goiter was treated with methimazole with gradual improvement but relapsed when it was stopped after 3 months. One week after switching to propylthiouracil (450 mg daily), she developed fatigue, vomiting and diarrhea followed by dark urine and jaundice. She remained symptomatic of her thyroid disease with tachycardia and tremor. On examination, she was jaundiced, but did not have fever, rash or signs of chronic liver disease. Laboratory tests showed bilirubin of 13.2 mg/dL and marked elevations of serum ALT (1501 U/L) and AST (2800 U/L), with minimal increase in alkaline phosphatase (287 U/L). Propylthiouracil was stopped and she was maintained on propranolol. Because of worsening liver failure she was transferred to a tertiary medical center. Tests for hepatitis A, B and C were negative as were antinuclear and smooth muscle antibodies. Thyroid studies showed a normal total and free thyroxine level. An open liver biopsy showed massive necrosis, and she underwent successful liver transplantation 10 days after onset of liver injury and 19 days after starting propylthiouracil.

#### Key Points

Medication: | Propylthiouracil (450 mg daily)
Pattern: | Hepatocellular (R=56)
Severity: | 5+ (emergency liver transplant)
Latency: | 1 week
Recovery: | None
Other medications: | Propranolol

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre (-60) | | 68 | 256 | 0.5 | Thyrotoxicosis
0 | | Propylthiouracil (450 mg daily) started
8 days | 0 | 2501 | | 13.2 | Drugs stopped
17 days | 9 days | | | 16.2
18 days | 10 days | 770 | 287 | 22.0
19 days | 11 days | Emergency liver transplantation
Normal Values | | <45 | <140 | <1.2

#### Comment

Many cases of acute liver failure attributable to propylthiouracil therapy have been reported in the literature, with several cases occurring in children or adolescents. This severe outcome has led to the recommendation that propylthiouracil not be used in children and not be considered as a first line of therapy for Graves disease in adults. The injury is typically hepatocellular and associated with rapid development of acute liver failure and death. The latency to onset can be short as in this instance (one week) or prolonged to as long as a year. This patient recovered after liver transplantation and was later treated successfully with subtotal thyroidectomy.

### Case 3. Severe acetaminophen hepatotoxicity after unintentional overdose.(3)

A 69 year old woman with chronic headaches taking high doses of acetaminophen and other analgesics and over-the-counter products developed drowsiness, poor appetite, nausea, vomiting and mild diarrhea. She was brought to the emergency room by her daughter who found her mother to be confused and not her usual highly functioning self. She had a history of mitral regurgitation and was taking warfarin chronically. She had no history of liver disease, alcohol use or risk factors for viral hepatitis. Medications being taken included Tylenol, Tylenol Sinus, Vicodin and tramadol, but the amounts being taken were not clear. The patient and her daughter denied that she was suicidal. On admission, serum acetaminophen levels were 133 mcg/dL. On examination, she was confused and had asterixis. Vital signs included pulse of 136/min, respirations 18/min, BP 127/64 and temperature 36.5 ^o^C. She had no signs of chronic liver disease. Serum bilirubin was 4.8 mg/dL, ALT 5,945 U/L, AST 12,476 U/L, and alkaline phosphatase was normal (Table). Tests for hepatitis A and B were negative as were autoantibodies. She had antibody to hepatitis C; HCV RNA testing was not performed. Abdominal ultrasound showed no evidence of biliary obstruction. She was given intravenous N-acetylcysteine and vitamin K. Within 2 days she began to improve clinically, and she was discharged after 7 days. In follow up 2 weeks later, all liver tests were normal and warfarin was restarted.

#### Key Points

Medication: | Acetaminophen (uncertain doses)
Pattern: | Hepatocellular (R>100) [alkaline phosphatase levels normal]
Severity: | Severe (jaundice, hospitalization and signs of hepatic failure)
Latency: | 5-7 days
Recovery: | ~2 weeks
Other medications: | Warfarin, tramadol, and oxycodone

#### Laboratory Values

Time After Stopping | ALT (U/L) | Bilirubin (mg/dL) | INR | Other
0 | 5945 | 4.8 | 3.7 | Asterixis
1 day | 4675 | 7.0 | 4.7
2 days | 3744 | 8.4 | 3.7
3 days | 1688 | 10.1 | 3.1 | Improved mentation
4 days | 1365 | 11.1 | 2.9
5 days | 855 | 12.1 | 2.6
6 days | 630 | 12.2 | 2.0 | Discharged
Normal Values | <42 | <130 | <1.2

#### Comment

This case is an example of unintentional or accidental acetaminophen overdose or "therapeutic misadventure" in an elderly lady who was taking several forms of acetaminophen over several days. Contributing factors may have been chronic hepatitis C, but the pattern of serum enzyme elevations and clinical course were typical of acetaminophen overdose and not likely to be due to acute viral hepatitis. The onset was "hyperacute" and typical of acute hepatic necrosis, with immediate appearance of hepatic failure and liver injury arising within days of starting the high doses of the medication. While intentional overdoses are associated with ingestion of at least 10 grams of acetaminophen at one time, unintentional overdoses are usually found with ingestion of somewhat lower amounts over a 3 to 5 day period, particularly in patients with malnutrition, alcoholism, chronic liver disease or an accompanying medical illness. Cases are frequently associated with use of narcotic combinations (such as hydrocodone with acetaminophen) with abuse of the narcotic leading to increasing acetaminophen exposure.

### Case 4. Acute liver failure and death due to diclofenac.(4)

A 65 year old woman with osteoarthritis developed the sudden onset of nausea, vomiting and fatigue six weeks after starting diclofenac 75 mg by mouth twice daily (having replaced ibuprofen therapy). Serum aminotransferase levels were minimally elevated (ALT 53 U/L, AST 40 U/L) having been normal 3 weeks earlier. Diclofenac was stopped and she was monitored. Five days later she was noted to be jaundiced and serum aminotransferase levels had risen precipitously (Table). She was treated with prednisone, but continued to worsen and was admitted for evaluation. Her other medications included furosemide (20 mg daily), famotidine (40 mg daily) and prednisone (30 mg daily). She did not use alcohol and had no history of liver disease or risk factors for viral hepatitis. On examination, she was jaundiced and lethargic. There was bilateral pitting edema, ascites and marked asterixis. Laboratory tests showed a total serum bilirubin of 36 mg/dL, ALT 140 U/L, AST 177 U/L and prothrombin time 15.8 seconds. Abdominal ultrasound showed a small liver with patent hepatic veins and no evidence of biliary obstruction. Tests for hepatitis A and B were negative as were autoantibodies. She subsequently had progressive hepatic failure and died 2 weeks after admission. Autopsy showed a shrunken liver with massive necrosis and severe cholestasis.

#### Key Points

Medication: | Diclofenac 75 mg twice daily
Pattern: | Hepatocellular (R=unable to calculate)
Severity: | 5+ (acute liver failure and death)
Latency: | 6 weeks
Recovery: | None
Other medications: | Furosemide, famotidine, prednisone

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | AST (U/L) | Bilirubin (mg/dL) | Other
3 weeks | | Normal | Normal | Normal | Diclofenac started
6 weeks | 0 | 53 | 40 | | Nausea and fatigue; diclofenac stopped
7 weeks | 5 days | | 3750 | 17.0 | Prednisone started
8 weeks | 2 weeks | 140 | 177 | 36.0 | Ascites and asterixis
10 weeks | 4 weeks | | | | Died of liver failure
Normal Values | | <45 | <45 | <1.2

#### Comment

This case is a dramatic example of precipitous drug induced acute liver failure. Diclofenac was discontinued promptly upon the development of symptoms of fatigue and nausea, at which time serum aminotransferase levels were only mildly elevated. Despite this, the patient developed jaundice and marked aminotransferase elevations a few days later, and subsequently showed signs of acute liver failure and died 3 weeks after onset of jaundice and 4 weeks after stopping diclofenac. The nonsteroidal antiinflammatory agents (NASIDs) are rare but well documented causes of acute liver failure. Diclofenac and sulindac have most frequently been associated with this severe form of idiosyncratic liver injury. The lack of cross reactivity to hepatic injury among different classes of NSAIDs is suggested by the history of tolerance of ibuprofen (a propionic acid NSAID in contrast to diclofenac, which belongs to the anthranilic acid class of NSAIDs).

## CITED REFERENCES

1 Farrell FJ, Keeffe EB, Man KM, Imperial JC, Esquivel CO. Treatment of hepatic failure secondary to isoniazid hepatitis with liver transplantation. Dig Dis Sc 1994; 39: 2255-9.7924752
2 Williams KV, Nayak S, Becker D, Reyes J, Burmeister LA. Fifty years of experience with propylthiouracil-associated hepatotoxicity: what have we learned? J Clin Endocrinol Metab 1997; 82: 1727-33.9177371
3 Acute Liver Failure Study Group Patient #2748.
4 Helfgott SM, Sandberg-Cook J, Zakim D, Nestler J. Diclofenac-associated hepatotoxicity. JAMA 1990; 264: 2660-2.2232043

## ANNOTATED BIBLIOGRAPHY

References updated: 11 December 2019

Helfgott SM, Sandberg-Cook J, Zakim D, Nestler J. Diclofenac-associated hepatotoxicity. JAMA 1990; 264: 2660-2. (7 cases of diclofenac hepatotoxicity; latency of 5 to 20 weeks, bilirubin 1.0 to 40.5 mg/dL, ALT 252 to 2409 U/L, Alk P 55 to 360 U/L, 6 with symptoms, 3 with jaundice, one died of hepatic failure: Case 4). 2232043
Farrell FJ, Keeffe EB, Man KM, Imperial JC, Esquivel CO. Treatment of hepatic failure secondary to isoniazid hepatitis with liver transplantation. Dig Dis Sci 1994; 39: 2255-9. (Two cases of acute liver failure attributed to isoniazid: 49 year old man on isoniazid for latent tuberculosis for 4 months developed jaundice [bilirubin 16.1 mg/dL, AST 2882 U/L], and 60 year old woman with onset of jaundice 6 weeks after starting isoniazid, rifampin, and pyrazinamide for active tuberculosis [bilirubin 3.5 mg/dL, AST 548 U/L]; both progressing to hepatic failure and undergoing successful transplant: Case 1). 7924752
Williams KV, Nayak S, Becker D, Reyes J, Burmeister LA. Fifty years of experience with propylthiouracil-associated hepatotoxicity: what have we learned? J Clin Endocrinol Metab 1997; 82: 1727-33. (Two cases: 14 year old girl developed jaundice 3 weeks after restarting propylthiouracil [bilirubin 13.2 mg/dL, ALT 2501 U/L, Alk P 287 U/L], progressing to hepatic failure and successful liver transplant, explant showing massive necrosis [Case 2]; 54 year old man with thyrotoxicosis and liver test abnormalities developed jaundice 2 weeks after starting propylthiouracil [bilirubin 5.8 to 23.5 mg/dL, ALT 740 U/L, Alk P 258 U/L], with progressive hepatic failure and death 5 weeks later; review of literature found 28 cases of propylthiouracil hepatotoxicity, 25 in women, 7 fatal). 9177371
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were for drug induced acute liver failure, 124 for acetaminophen and 137 for other agents, the most common being isoniazid [n=24], propylthiouracil [13], phenytoin [10], valproate [10], amanita [9], nitrofurantoin [7], herbal supplements [7], ketoconazole [6], disulfiram [6], troglitazone [4] and 28 others). 15390328
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports of drug induced liver injury to a Spanish network found 570 cases, diclofenac ranked 7th with 12 cases, 10 hepatocellular, none fatal). 16083708
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002: 103 cases identified as highly probable, probable or possible, most common causes being halothane [16], acetaminophen [14], flucloxacillin [9], TMP/SMZ [6], dextroproxifen [4], ciprofloxacin [3], disulfiram [3], diclofenac [3], naproxen [3] and the sulfonamides [3]). 16165719
Larson AM, Polson J, Fontana RJ, Davern TJ, Lalani E, Hynan LS, Reisch JS, et al.; Acute Liver Failure Study Group. Acetaminophen-induced acute liver failure: results of a United States Multicenter, Prospective Study. Hepatology 2005; 42: 1364-72. (In a 6 year study at 22 US centers, 275 of 662 cases [42%] of acute liver failure were due to acetaminophen accounting for 1/3rd of deaths; frequency increased over time from 28% to 51%; 65% spontaneous survival, 8% transplanted, 27% died; ~ half were unintentional with average total dose of 20 vs 25 grams exposure; similar course and outcome to intentional overdose cases). 16317692
Ijaz K, Jereb JA, Lambert LA, Bower WA, Spradling PR, McElroy PD, Iademarco MF, et al. Severe or fatal liver injury in 50 patients in the United States taking rifampin and pyrazinamide for latent tuberculosis infection. Clin Infect Dis 2006; 42: 346-55. (Analysis of 50 cases of severe hepatotoxicity from rifampin/pyrazinamide therapy of latent tuberculosis occurring in US between 1998-2004 and arising during or within 1 month of stopping therapy; fatality rate higher in older patients and with later onset; patients frequently on other potentially hepatotoxic medications). 16392079
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports: 89% from the US; 21 drugs were associated with >50 cases included [in order] acetaminophen, troglitazone, valproate, stavudine, halothane, lamivudine, didanosine, amiodarone, nevirapine, SMZ-TMP, flutamide, phenytoin, isoniazid, trovafloxacin, diclofenac, oxycodone, cyclophosphamide, zidovudine, methotrexate, cytarabine, and clarithromycin). 16054882
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network(DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 8 patients died of acute liver failure and 9 underwent liver transplantation within 6 months of onset, implicated drugs including nitrofurantoin, levofloxacin, interferon beta, terbinafine, leflunomide, telithromycin, simvastatin/ezetimibe, and bupropion). 18955056
Fontana RJ. Acute liver failure including acetaminophen overdose. Med Clin North Am 2008; 92: 761-94. (Review of clinical features, diagnosis, complications, and management of acute liver failure). 18570942
Fontana RJ. Acute liver failure due to drugs. Semin Liver Dis 2008; 28: 175-87. (Review of the causes, diagnosis and management of drug induced acute liver failure: mostly commonly implicated agents are acetaminophen, antibiotics, anticonvulsants and herbal preparations). 18452117
Murray KF, Hadzic N, Wirth S, Bassett M, Kelly D. Drug-related hepatotoxicity and acute liver failure. J Pediatr Gastroenterol Nutr 2008; 47: 395-405. (Drugs account for 20% of acute liver failure in children, mostly due to acetaminophen [14%], but also attributed to idiosyncratic injury due to other agents [5%], including valproate, isoflurane, methotrexate, cyclosphosphamide, isoniazid, TMP/SMZ and minocycline. 18852631
Lee WM, Hynan LS, Rossaro L, Fontana RJ, Stravitz RT, Larson AM, Davern TJ 2nd, et al.; Acute Liver Failure Study Group. Intravenous N-acetylcysteine improves transplant-free survival in early stage non-acetaminophen acute liver failure. Gastroenterology 2009; 137: 856-64. (Placebo controlled trial of intravenous N-acetylcysteine in 173 patients with acute liver failure not due to acetaminophen found improved spontaneous survival with treatment [40%] compared to placebo [27%] and particularly with idiosyncratic drug induced liver failure [58% vs 27%]). 19524577
Bernal W, Auzinger G, Dhawan A, Wendon J. Acute liver failure. Lancet 2010; 376(9736): 190-201. (Review describes acute liver failure caused by acetaminophen as "hyperacute", with rapid onset of encephalopathy, severe coagulopathy, mild to moderate jaundice and high rate of survival without transplantation; accounting for 36-57% of cases in UK, US, Australia and Sweden, but only 2% in Spain and <1% in India, Pakistan and the Sudan). 20638564
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including isoniazid [21], nitrofurantoin [11], phenytoin [8], propylthiouracil [5], disulfiram [4], bromfenac [4], troglitazone [4], carbamazepine [3], terbinafine [3], sulfonamides [12], statins [6] and miscellaneous herbal supplements [14]). 20949552
Lee WM, Larson AM, Stravitz RT. AASLD Position Paper: The management of acute liver failure: Update 2011. Available at: https://www.aasld.org/sites/default/files/2023-03/Acute%20Liver%20Failure%20Update2011.pdf
Reuben A, Tillman H, Fontana RJ, Davern T, McGuire B, Stravitz RT, Durkalski V, et al. Outcomes in adults with acute liver failure between 1998 and 2013: an observational cohort study. Ann Intern Med 2016; 164: 724-32.27043883
Figiel W, Morawski M, Grąt M, Kornasiewicz O, Niewiński G, Raszeja-Wyszomirska J, Krasnodębski M, et al. Fulminant liver failure following a marathon: five case reports and review of literature. World J Clin Cases 2019; 7: 1467-74.31363475
Stravitz RT, Lee WM. Acute liver failure. Lancet 2019; 394(10201): 869-81.31498101
Chayanupatkul M, Schiano TD. Acute liver failure secondary to drug-induced liver injury. Clin Liver Dis 2020; 24: 75-87.31753252